# Vanishing Bile Duct Syndrome

Description. Vanishing bile duct syndrome (VBDS) is a rare but serious outcome and complication of drug induced liver injury marked clinically by chronic cholestasis and histologically by loss of intrahepatic bile ducts. VBDS typically occurs after a bout of severe cholestatic hepatitis, often with immunoallergic features.

Latency to Onset. VBDS is a complication of acute drug induced liver injury, generally becoming manifest 1 to 6 months after the onset of injury.

Symptoms. Typical symptoms of VBDS are persistent pruritus, fatigue and jaundice, sometimes with severe dyslipidemia, hypercholesterolemia and skin xanthomata that can be painful and interfere with everyday activities, particularly when present on palms and soles.

Serum Enzyme Elevations. VBDS typically arises in the setting of severe acute cholestatic hepatitis in which there is an inadequate recovery as shown by persistent elevations in alkaline phosphatase levels and bilirubin, which often occur despite a decrease in serum aminotransferase levels into the normal or near-normal range. Serum cholesterol levels are also raised as are serum bile acid levels.

Drugs. Drugs that have been implicated in causing VBDS include amoxicillin/clavulanate, other penicillins, macrolide antibiotics, fluoroquinolones, sulfonamides, antifungal agents, nonsteroidal antiinflammatory agents, phenothiazines, tricyclic antidepressants and aromatic anticonvulsants. However, any cause of severe acute cholestatic or mixed hepatitis may lead to VBDS. A list of medications linked to at least one case of VBDS in the literature is given below.

Differential Diagnosis. Other conditions that can mimic or cause vanishing bile duct syndrome include graft-vs-host disease, Hodgkin's disease, sclerosing cholangitis and primary biliary cholangitis. These conditions are readily excluded based upon clinical setting, medical history and serological testing.

Criteria for Definition. VBDS is a pathological diagnosis although certainly the condition can be diagnosed clinically without liver histology. Furthermore, there are great variations in severity and outcome of VBDS. Most cases of VBDS arise within a few months of onset of severe cholestatic hepatitis, often with immunoallergic features such as rash, fever, facial edema, lymphadenopathy and eosinophilia; and in more dramatic cases with Stevens Johnson syndrome or toxic epidermal necrolysis. VBDS can be relentless and progressive, with almost complete loss of bile ducts accompanied by severe cholestasis and hepatic failure leading to death or need for liver transplantation within 1 to 3 years of onset. In other situations, the bile duct loss is partial and early but not progressive and ultimately reverses, at least partially. In many instances, clinical recovery occurs but there is evidence of residual chronic liver injury, with mild pruritus and abnormal serum enzymes and liver biopsy showing hepatic fibrosis and a relative decrease in hepatic ducts (ductopenia). In the mildest forms, patients may recover clinically and no longer have symptoms or jaundice, but exhibit persistent alkaline phosphatase and GGT elevations and have a relative paucity of bile ducts if a liver biopsy is performed. The diagnosis of VBDS, and particularly its milder forms, requires expertise in hepatic pathology and a liver biopsy with adequate numbers of portal areas to fully assess bile duct loss. Elements in the diagnosis of VBDS are:

1 Persistent elevations in serum alkaline phosphatase and bilirubin for more than 6 months after onset of drug induced liver disease
2 Absence of clinical or serologic evidence of primary biliary cholangitis, sclerosing cholangitis and graft-vs-host disease
3 Liver biopsy findings of paucity of intralobular bile ducts (<50% of portal areas with bile duct in a biopsy with at least 10 portal areas) in a sample taken at least 1 month after onset of injury.

The diagnosis can also be considered if there are persistent elevations in serum alkaline phosphatase and/or GGT for more than 12 months after onset of drug induced liver injury, particularly if a liver biopsy demonstrates a decrease in intralobular bile ducts (as shown by <50% of portal areas with an intralobular bile duct in a biopsy with at least 10 portal areas). Mild, partial or "incomplete" forms of vanishing bile duct syndrome may be accompanied by lesser decrease in bile ducts, with 50-75% of portal areas having an identifiable intralobular bile duct.

Management. VBDS may be accompanied by troublesome symptoms including pruritus, fatigue and hypercholesterolemia with xanthomata. Mild pruritus can be managed with antihistamines such as diphenhydramine and hydroxyzine. The sedative effects of these antihistamines may be beneficial as pruritus can be worse at night and disturb sleep. With more difficult pruritus, bile acid resins such as cholestyramine and colistipol may be helpful as they can bind and trap pruritogenics in the intestine. These agents, however, are not always well tolerated and must be taken before meals and in adequate doses. Other less well established treatments for pruritus include rifampin and naltrexone which have been reported to be beneficial in small case series. Hyperlipidemia may require therapy as well and it responds minimally to HMG Coenzyme A inhibitors (statins) which are best avoided. Severe hyperlipidemia with painful xanthomata may plasma exchange for management. Indeed, severe intractable pruritus can be an indication for liver transplantation. Corticosteroids are often used in treatment of severe cholestasis and VBDS, but there is no evidence that they are beneficial and they can worsen the secondary metabolic effects of end stage liver disease and cholestasis. Ursodiol is almost universally used in the treatment of VBDS, and while prospective controlled trials have not been conducted to demonstrate their benefit, anecdotal reports have suggested that they are beneficial in ameliorating the injury. Importantly, VBDS can slowly resolve on its own and a major focus of management should be avoidance of further injury. Careful attention to nutrition and vitamin and mineral replacement (vitamin D, E, K and calcium) are important in managing patients with this rare but challenging condition. Experimental approaches to treating VBDS include immunosuppression with calcineurin inhibitors or monoclonal antibodies. Despite all interventions, however, a proportion of patients with VBDS due to medications eventually develop cirrhosis and end stage liver disease requiring liver transplantation.

## Drugs Associated with Vanishing Bile Duct Syndrome

Drug Class | Specific Agents
Antibiotics
Penicillins | Amoxicillin, Amoxicillin/Clavulanic Acid, Flucloxacillin
Cephalosporins | Cefdinir, Cefazolin, Cephalexin
Fluoroquinolones | Ciprofloxacin, Levofloxacin, Moxifloxacin
Sulfonamides | (Trimethoprim)-Sulfamethoxazole
Macrolides | Azithromycin, Erythromycin
Lincomycins | Clindamycin
Tetracyclines | Troleandomycin
Carbapenems | Meropenem
Antiviral Agents | Nevirapine
Antifungal Agents | Itraconazole, Terbinafine
Anthelmintic Agents | Thiabendazole
Antimalarial Agents | Atovaquone-Proguanil
Anticonvulsants | Carbamazepine, Oxcarbazepine, Phenytoin, Valproate, Phenobarbital, Lamotrigine, Zonisamide
Antidepressants | Amitriptyline, Imipramine, Sertraline
Antipsychotic Agents | Olanzapine, Haloperidol, Phenothiazines
Lipid lowering Agents | Atorvastatin, Fenofibrate
Rheumatologic Agents | Allopurinol, Azathioprine, Infliximab, Gold
Antineoplastic Agents | Temozolomide, Thalidomide, Lenalidomide
Hormones | Anabolic Steroids, Estrogens
NSAIDs | Ibuprofen, Acetaminophen, Celecoxib, Phenylbutazone
Antidiabetic Agents | Glibenclamide, Tolbutamide
Herbal Agents | Glycyrrhizin, Artemisinin, Tibolone
Gastrointestinal Agents | Cimetidine, Metoclopramide, Lansoprazole, Omeprazole
Respiratory Agents | Cromolyn, Montelukast
Cardiovascular Agents | Hydrochlorothiazide, Enalapril

Agents in bold font are the most frequently reported causes of VBDS. Agents in some general classes such as the macrolide and fluoroquinolone antibiotics may all be capable of causing this complication of acute cholestatic hepatitis.

## CASE REPORTS

### Case 1. Prolonged cholestatic liver injury and vanishing bile duct syndrome due to prochlorperazine.(1)

A 68 year old man was treated with trimethoprim/sulfamethoxazole (800/400 mg three times daily) for one week and prochlorperazine (10 mg daily) for 4 weeks for suspected otitis media. A few weeks after stopping prochlorperazine he developed jaundice and pruritus. When first seen one month after stopping medications, serum bilirubin was 18.4 mg/dL, alkaline phosphatase was 1.5 times normal and ALT was minimally elevated (Table). Tests for viral hepatitis and abdominal ultrasound were normal. After persistence of jaundice for 3 months, a liver biopsy was done which showed centrilobular cholestasis with minimal hepatocyte necrosis or portal inflammation. The intralobular bile ducts were normal. He continued to have jaundice and severe pruritus and developed skin hyperpigmentation. Tests for hepatitis B and mitochondrial antibody were negative. Endoscopic retrograde cholangiopancreatography was normal. Serum bilirubin levels peaked 4 months after presentation and then began to decline, not becoming normal until one year later. Pruritus and hyperpigmentation also resolved, but serum alkaline phosphatase and GGT levels remained elevated. A repeat liver biopsy, done two years after onset and 9 months after resolution of jaundice and symptoms, showed minimal cholestasis but bridging hepatic fibrosis and paucity of intralobular bile ducts. Two and a half years after onset, serum alkaline phosphatase levels were still abnormal but he had no symptoms.

#### Key Points

Medication: | Prochlorperazine (10 mg daily for 4 weeks)
Pattern: | Cholestatic
Severity: | 4+ (prolonged jaundice and hepatic fibrosis)
Latency: | 4 weeks
Recovery: | Incomplete after 2 years
Other medications: | Trimethoprim/sulfamethoxazole

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
| | Prochlorperazine (10 mg daily)
1 month | 0 | 49 | 116 | 18.4
| 3 months | 80 | 210 | 26.2 | Biopsy #1
| 4 months | 88 | 219 | 19.3 | ERCP normal
| 6 months | 85 | 365 | 11.2
| 10 months | 65 | 430 | 2.6
1 year | 12 months | 60 | 410 | 1.5
2 years | 22 months | 85 | 445 | 1.0 | Biopsy #2
Normal Values | | <42 | <90 | <1.2

* Some values estimated from Figure 1 and bilirubin converted from µmol/L to mg/dL.

#### Comment

An example of the evolution of an acute cholestatic hepatitis to prolonged cholestasis and VBDS. The patient eventually improved and was asymptomatic, but alkaline phosphatase levels were persistently elevated and liver biopsy showed paucity of intralobular bile ducts and bridging hepatic fibrosis 2 years after initial onset. Not all cases of VBDS progress to hepatic failure and eventual clinical improvement is common and may be accompanied by reappearance of bile ducts. Long term follow up on such cases usually demonstrates well compensated and nonprogressive liver disease with fibrosis and persistence of mild elevations in serum alkaline phosphatase.

### Case 2. Acute cholestatic hepatitis due to chlorpromazine evolving into chronic cholestatic syndrome with vanishing bile duct syndrome.(2)

A 34 year old pregnant woman was treated with chlorpromazine (25 mg twice daily) for hyperemesis gravidarum and developed fatigue and dark urine 2 weeks later followed by pruritus and jaundice. Chlorpromazine was stopped. Blood testing showed marked increases in serum bilirubin, ALT and alkaline phosphatase (Table). Tests for acute hepatitis A, B and C were negative as were autoantibodies including antinuclear, smooth muscle and mitochondrial antibodies. She had no previous history of liver disease, risk factors for viral hepatitis or alcohol abuse. She was approximately 2 months pregnant. She remained jaundiced throughout pregnancy that was terminated by Caesarian section at week 28. A concurrent liver biopsy showed severe intrahepatic cholestasis, portal inflammation and bile duct injury. After delivery of twin girls she remained jaundiced and had persistent and unrelenting pruritus. Various therapies including antihistamines, phenobarbital, cholestyramine, S-adenosylmethionine, prednisone, phototherapy and plasmapheresis were of minimal benefit. A repeat liver biopsy at 8 months after onset showed increased cholestasis and reduction in number of bile ducts and a third liver biopsy after 14 months showed bridging fibrosis and paucity of bile ducts (detectable in only 3 of 16 portal tracts). She had enlargement of the liver and spleen, marked weight loss, steatorrhea, and symptoms of severe pruritus and fatigue. She was started on ursodiol (900 mg daily) and simultaneously began to improve clinically. Jaundice resolved 20 months after initial onset after which serum alkaline phosphatase and ALT levels fell into the range of 1.5 to 3 fold elevated. Serum albumin and prothrombin time remained normal throughout the course. Ultrasound of the abdomen showed changes suggestive of cirrhosis and a fourth liver biopsy, 46 months after initial onset, showed biliary cirrhosis with minimal inflammation and focal areas of cholestasis and bile duct paucity (ducts detected in 5 of 12 portal tracts).

#### Key Points

Medication: | Chlorpromazine (50 mg daily for 20 days)
Pattern: | Cholestatic (R=~0.1 at peak)
Severity: | 4+ (prolonged jaundice, cirrhosis)
Latency: | 2 weeks
Recovery: | Incomplete after 4 years
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Pre | Chlorpromazine (50 mg daily for 20 days) given for nausea
3 weeks | 0 | 60 | 100 | 7.0 | 2 months pregnant
5 months | 4 months | 60 | 510 | 35.0 | Delivery: liver biopsy #1
| 6 months | 120 | 400 | 22.0
| 8 months | 184 | 4128 | 32.7 | Liver biopsy #2
| 10 months | 140 | 1800 | 19.0
| 12 months | 150 | 2100 | 22.9
| 14 months | 110 | 550 | 20.5 | Liver biopsy #3
| 4 years | 100 | 280 | 1.5 | Liver biopsy #4
Normal Values | | <42 | <90 | <1.2

* Some values estimated from Figure 4 and bilirubin converted from µmol/L to mg/dL.

#### Comment

A typical cholestatic hepatitis from chlorpromazine was followed by persistent cholestasis with jaundice and pruritus. Her pregnancy was terminated early because of the jaundice, with a Caesarian section during which a liver biopsy was done which showed severe cholestatic hepatitis with bile duct injury. Follow up liver biopsies at 8, 12 and 46 months after onset showed loss of bile ducts but, eventually, a gradual improvement in cholestasis. Nevertheless, the patient developed cirrhosis and the long term prognosis remains uncertain. This is a dramatic and well documented example of VBDS developing after an acute cholestatic hepatitis due to chlorpromazine. Ursodiol therapy appeared to improve both symptoms and laboratory test results, but some degree of clinical improvement had started before therapy was initiated. Many instances of vanishing bile duct syndrome due to chlorpromazine have been published. Ursodiol is often used, but its efficacy in ameliorating or shortening the course of illness is not clear. It is appropriate to use particularly if there is symptomatic improvement.

### Case 3. Vanishing bile duct syndrome after acute cholestatic injury attributed to ibuprofen.(3)

A 29 year old man with history of multiple allergies developed jaundice and abdominal pain 3 weeks after starting low doses of ibuprofen (600 mg/day) for nonspecific body aches. He was admitted with the suspected diagnosis of cholangitis, and ibuprofen was stopped. Serum bilirubin was 6.5 mg/dL and both ALT and alkaline phosphatase were moderately elevated (Table). He had no risk factors for viral hepatitis and denied alcohol abuse. Serologic tests for hepatitis A, B and C were negative as were autoantibodies including ANA and AMA. Ultrasound of the abdomen showed no evidence of gallstones or biliary obstruction. He was treated with antibiotics, but jaundice worsened and he developed pruritus. A liver biopsy showed intrahepatic cholestasis, marked portal inflammatory infiltrates with damage to and reduced numbers of bile ducts in portal areas. An endoscopic retrograde cholangiopancreatography (ERCP) was normal. A course of corticosteroids had no apparent effect, and serum bilirubin levels continued to rise. A second liver biopsy 6 weeks after onset showed less portal inflammation, but worsening cholestasis and further decrease in numbers of small bile ducts. Therapy for pruritus included antihistamines, ursodiol and cholestyramine with only modest effects. A third biopsy at 6 months showed markedly reduced bile ducts ("ductopenia"). At 12 months, he continued to be deeply jaundiced and was symptomatic with marked pruritus and xanthomata. He was referred for liver transplantation.

#### Key Points

Medication: | Ibuprofen (600 mg daily)
Pattern: | Initially mixed (R=4.5), later cholestatic (R=<1.0)
Severity: | 4+ (jaundice, hospitalization, progressive hepatic failure)
Latency: | 3 weeks
Recovery: | No; jaundice and vanishing bile duct syndrome one year later
Other medications: | Allergy injections for six weeks before onset

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Ibuprofen started
3 weeks | 0 | 488 | 309 | 6.5 | Hospitalized, Ibuprofen stopped
5 weeks | 2 weeks | 400 | 2151 | 11.9 | First liver biopsy, ERCP normal
7 weeks | 4 weeks | 150 | 750 | 24.0
4 months | 3 months | 300 | 1000 | 21.0 | Second liver biopsy
6 months | 5 months | 180 | 850 | 16.5
8 months | 7 months | 140 | 4000 | 19.0 | Third liver biopsy
10 months | 9 months | 200 | 900 | 8.0
1 year | 11 months | 300 | 3000 | 13.0 | Referred for liver transplant
Normal Values | | <41 | <115

#### Comment

Clinically apparent, acute liver injury from ibuprofen is very rare. This case was associated with a latency of 3 weeks and presentation with an acute cholestatic hepatitis that evolved into chronic cholestasis and the VBDS. On the first determination, the serum enzyme pattern was "mixed," but it rapidly became distinctly cholestatic, matching the symptoms of deep jaundice and pruritus as well as the liver biopsy showing marked cholestasis with scant hepatocellular injury. The rapid onset followed by prolonged course of cholestasis combined with a history of allergies point towards an immunoallergic mechanism for this reaction. The patient had a decreased number of bile ducts on initial liver biopsy, which became progressively fewer on follow up biopsies, thus demonstrating the progressive nature of vanishing bile duct syndrome. This poor outcome occurred despite prompt discontinuation of the medication. The course of vanishing bile duct syndrome is variable, some patients eventually recover, but it can be unremitting, severe, leading as in this case to need for liver transplantation or death.

### Case 4. Fatal case of vanishing bile duct syndrome after amoxicillin/clavulanate therapy.(4)

A 78 year old woman received a one week course of amoxicillin/clavulanate with tenoxicam for cervical pain and fever. At the end of antibiotic therapy, she was diagnosed as having cluster headaches and prednisolone was started. At that point, all liver tests were normal. Her headaches improved, but 6 weeks later she developed jaundice, pruritus and abdominal pain. On admission, she was jaundiced but was without fever, rash or stigmata of chronic liver disease. Serum bilirubin was 6.3 mg/dL, ALT 775 U/L, and alkaline phosphatase 245 U/L. Tests for viral hepatitis and autoantibodies were negative and imaging tests showed no evidence of biliary obstruction. Prednisolone was continued, but her jaundice worsened and serum alkaline phosphatase levels continued to rise (Table). Liver biopsy showed marked centrilobular cholestasis, minimal hepatocyte necrosis and mild portal inflammation. Importantly, interlobular bile ducts were absent in 6 of 12 portal tracts, and the ducts that were present had dystrophic changes. In the course of the following months, her condition worsened with progressive weakness, poor appetite, weight loss, intractable pruritus and appearance of keratoconjunctivitis sicca. Ursodiol was given without improvement. Death from hepatic failure occurred 4 months after initial presentation.

#### Key Points

Medication: | Amoxicillin/clavulanic acid (500/125 mg three times daily for 10 days)
Pattern: | Initially hepatocellular (R=10.2) and later cholestatic (R=0.3)
Severity: | 5+ (fatal)
Latency: | 8 weeks (6 weeks after stopping drug)
Recovery: | No
Other medications: | Tenoxicam, prednisone

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
0 | Pre | Amoxicillin/clavulanate given for 10 days
2 weeks | 4 days | 20 | 60 | 1.0 | Shortly after stopping antibiotic
8 weeks | 6 weeks | 775 | 245 | 6.3 | Hospitalization
9 weeks | 7 weeks | 480 | 585 | 23.4 | Liver biopsy: bile duct paucity
11 weeks | 9 weeks | 160 | 650 | 12.9
12 week | 10 weeks | 232 | 884 | 21.9
14 weeks | 12 weeks | 116 | 793 | 21.3 | Ursodiol started
17 weeks | 15 weeks | 88 | 780 | 13.2
19 weeks | 17 weeks | 40 | 858 | 11.1
5 months | 20 weeks | 88 | 936 | 12.9
6 months | | 129 | 1040 | 12.6 | Death
Normal Values | | <40 | <130 | <1.2

* Estimated from figure 1.

#### Comment

This case is an example of a relentless and rapidly fatal course of VBDS with persistence of deep jaundice and pruritus. Interestingly, the pattern of serum enzyme elevations was initially hepatocellular (R=10.2), but the pattern soon changed to a cholestatic index (R=0.3). The appearance of keratoconjunctivitis sicca suggests that the epithelial cell injury was widespread, also affecting the small ducts of the salivary and lacrimal glands (a pattern that occurs with other causes of VBDS). Tenoxicam (a nonsteroidal antiinflammatory agent [NSAID]) was started and stopped at the same time as the antibiotic, and might also have contributed (several NSAIDs have been linked to VBDS), but the timing of onset of cholestatic hepatitis is also typical for amoxicillin/clavulanate hepatotoxicity. The patient received prednisolone for the whole course of illness and ursodiol was added during the cholestatic phase without obvious evidence for benefit of either.

## CITED REFERENCES

1 Lok AS, Ng IO. Prochlorperazine-induced chronic cholestasis. J Hepatol 1988; 6: 369-73.3392386
2 Moradpour D, Altorfer J, Flury R, Greminger P, Meyenberger C, Jost R, Schmid M. Chlorpromazine-induced vanishing bile duct syndrome leading to biliary cirrhosis. Hepatology 1994; 20: 1437-41.7982642
3 Alam I, Ferrell LD, Bass NM. Vanishing bile duct syndrome temporally associated with ibuprofen use. Am J Gastroenterol 1996; 91: 1626-30.8759674
4 Richardet JP, Mallat A, Zafrani ES, Blazquez M, Bognel JC, Campillo B. Prolonged cholestasis with ductopenia after administration of amoxicillin/clavulanic acid. Dig Dis Sci 1999; 44: 1997-2000.10548348

## ANNOTATED BIBLIOGRAPHY

References updated: 11 December 2019

Zimmerman HJ. Cholestatic injury. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 434-7. (Expert review of hepatotoxicity published in 1999; discusses chronic cholestatic injury that can resemble primary biliary cirrhosis and result in loss of bile ducts; more than 3 dozen agents have been associated with VBDS including amitriptyline, amoxicillin-clavulanate, azathioprine, carbamazepine, clindamycin, erythromycin, fluoroquinolones, imipramine, phenytoin, phenothiazines, SMZ-TMP, tetracycline, terbinafine, and thiabendazole).
Read AE, Harrison CV, Sherlock S. Chronic chlorpromazine jaundice: with particular reference to its relationship to primary biliary cirrhosis. Am J Med 1961; 31: 249-58. (4 women developed prolonged jaundice due to chlorpromazine, ages 28 to 57 years, onset in 2-4 weeks, jaundice lasting for 7-36 months, peak bilirubin 15-21.6 mg/dL, Alk P 5-20 times ULN, high cholesterol, xanthomas and weight loss in 3, itching in all; all women, 2 pregnant; ultimately slow recovery but residual biochemical and histologic abnormalities and fibrosis frequent; probable vanishing bile duct syndrome). 13740051
Horst DA, Grace ND, LeCompte PM. Prolonged cholestasis and progressive hepatic fibrosis following imipramine therapy. Gastroenterology 1980; 79: 550-4. (53 year old woman developed rash and fever 7 days after starting imipramine followed by jaundice with eosinophilia [bilirubin 10 mg/dL, AST 115 U/L, Alk P ~4 times ULN] with persistent jaundice and severe pruritus for 1 year, followed by gradual improvement; but 12 year follow up showed minor alkaline phosphatase and AST elevations with normal bilirubin; liver biopsies showed duct absence initially, but returning in follow up, although fibrosis was present). 7429116
Turner IB, Eckstein RP, Riley JW, Lunzer MR. Prolonged hepatic cholestasis after flucloxacillin therapy. Med J Aust 1989; 151: 701-5. (5 cases of cholestatic hepatitis arising after stopping flucloxacillin with latency of 13-35 days [bilirubin 13.3-38.2 mg/dL, ALT 85-525 U/L, Alk P 263-1580 U/L], with prolonged jaundice and abnormal liver tests still present 4-9 months later suggestive of VBDS). 2593915
Lok AS, Ng IO. Prochlorperazine-induced chronic cholestasis. J Hepatol 1988; 6: 369-73. (68 year old man developed jaundice 4 weeks after starting prochlorperazine [peak bilirubin 26 mg/dL, ALT 50-90 U/L, Alk P 120-500 U/L], jaundice and pruritus persisting for more than a year, but then gradual clinical improvement but with persistent enzyme elevations, and biopsy 22 months after onset showed fibrosis and paucity of bile ducts: Case 1). 3392386
Bach N, Thung SN, Schaffner F, Tobias H. Exaggerated cholestasis and hepatic fibrosis following simultaneous administration of chlorpromazine and sodium valproate. Dig Dis Sci 1989; 34: 1303-7. (45 year old man developed fatigue and fever 12 days after starting chlorpromazine for intractable hiccups [bilirubin 21.5 mg/dL, ALT 1312 U/L, Alk P 617 U/L], with persistent jaundice and pruritus for several years and eventual presence of cirrhosis and varices; paucity of bile ducts on biopsy indicating VBDS). 2502367
Sherlock S. The syndrome of disappearing intrahepatic bile ducts. Lancet 1987; 2: 493-6. (Concise overview of the clinical and histological features, outcome and causes of VBDS: drug induced causes were not discussed). 2887786
Larrey D, Amouyal G, Danan G, Degott C, Pessayre D, Benhamou JP. Prolonged cholestasis after troleandomycin-induced acute hepatitis. J Hepatol 1987; 4: 327-9. (62 year old woman given multiple antibiotics including 6 days of troleandomycin when she developed jaundice and pruritus [bilirubin 3.0 rising to 9.8 mg/dL, ALT ~7 times ULN, Alk P 4.5 times ULN], biopsy after one month showing no loss of ducts, but jaundice was slow to clear [3 months] and pruritus lasted 1.5 years later). 3496378
Cavanzo FJ, Garcia CF, Botero RC. Chronic cholestasis, paucity of bile ducts, red cell aplasia, and the Stevens-Johnson syndrome. An ampicillin-associated case. Gastroenterology 1990; 99: 854-6. (35 year old woman developed Stevens-Johnson syndrome with cholestatic hepatitis and red cell aplasia 4 days after starting oral ampicillin with subsequent prolonged cholestasis and VBDS but with gradual improvement after several years). 2116345
Degott C, Feldmann G, Larrey D, Durand-Schneider AM, Grange D, Machayekhi J-P, Moreau A, et al. Drug-induced prolonged cholestasis in adults: a histological semiquantitative study demonstrating progressive ductopenia. Hepatology 1992; 15: 244-51. (Clinical and histological description of drug induced prolonged cholestasis and ductopenia, the severe form of which can lead to VBDS, cirrhosis and hepatic failure: 8 cases with 3 due to ajmaline and one each to cyamemazine, troleandomycin, erythromycin, amitriptyline, and cyproheptadine). 1735527
Forbes GM, Jeffrey GP, Shilkin KB, Reed WD. Carbamazepine hepatotoxicity: another cause of the vanishing bile duct syndrome. Gastroenterology 1992; 102: 1385-8. (59 year old man developed fever, rash and jaundice 2 months after starting carbamazepine [bilirubin 12.4 mg/dL, AST 99 U/L, Alk P 1030 U/L], evolving into chronic cholestasis and VBDS, which ultimately improved clinically, but liver tests were still abnormal 1 year later). 1551543
Altraif I, Lilly L, Wanless IR, Heathcote J. Cholestatic liver disease with ductopenia (vanishing bile duct syndrome) after administration of clindamycin and trimethoprim-sulfamethoxazole. Am J Gastroenterol 1994; 89: 1230-4. (Two cases of VBDS: Case 1 was a 67 year old man with jaundice arising 1 week after completion of a 10 day course of clindamycin [bilirubin 14.6 mg/dL, ALT 315 U/L, Alk P 271 U/L, GGT 468 U/L], followed by prolonged jaundice for 2-4 years [bilirubin 4.2 mg/dL, Alk P 179 U/L, ALT 67 U/L], liver biopsies showing progressive loss of bile ducts; Case 2 was 30 year old man with TMP/SMZ induced allergic hepatitis with jaundice evolving into a prolonged cholestatic syndrome and ductopenia). 8053440
Moradpour D, Altorfer J, Flury R, Greminger P, Meyenberger C, Jost R, Schmid M. Chlorpromazine-induced vanishing bile duct syndrome leading to biliary cirrhosis. Hepatology 1994; 20: 1437-41. (33 year old pregnant woman had onset of jaundice 2 weeks after starting chlorpromazine, jaundice lasting 22 months with pruritus and high Alk P; ultimately resolving jaundice but with biliary cirrhosis and absence of bile ducts: Case 2). 7982642
Davies MH, Harrison RF, Elias E, Hübscher SG. Antibiotic-associated acute vanishing bile duct syndrome: a pattern associated with severe, prolonged, intrahepatic cholestasis. J Hepatol 1994; 20: 112-6. (Two cases of VBDS: 37 year old woman developed rash within one day of starting amoxicillin and jaundice one week later, liver biopsies showing paucity of bile ducts and cholestasis lasting 16 months; 42 year old woman developed jaundice 2 weeks after finishing a 14 day course of flucloxacillin, liver biopsy showing on bile ducts in portal areas [0%], but follow up biopsies demonstrating gradual increase to 50%). 8201211
Ryley NG, Fleming KA, Chapman RW. Focal destructive cholangiopathy associated with amoxicillin/clavulanic acid (Augmentin). J Hepatol 1995; 23: 278-82. (Five patients developed jaundice and cholestatic hepatitis after receiving amoxicillin/clavulanate, and all had destructive cholangitis on liver biopsy, but only one patient continued to have abnormal liver tests beyond six months). 8550991
O'Brien CB, Shields DS, Saul SH, Reddy KR. Drug-induced vanishing bile duct syndrome: response to ursodiol. Am J Gastroenterol 1996; 91: 1456-7. (58 year old woman developed jaundice 6 weeks after starting phenytoin and prochlorperazine [bilirubin 11.8 mg/dL, ALT 139 U/L, Alk P 1797 U/L], liver biopsy showing ductal paucity; subsequent persistent pruritus and Alk P elevations [800 U/L], improved with starting ursodiol therapy with ultimate resolution). 8678017
Alam I, Ferrell LD, Bass NM. Vanishing bile duct syndrome temporally associated with ibuprofen use. Am J Gastroenterol 1996; 91: 1626-30. (29 year old man developed acute cholestatic hepatitis followed by vanishing bile duct syndrome after a 3 week course of ibuprofen: Case 3). 8759674
Mallat A, Zafrani ES, Metreau JM, Dhumeaux D. Terbinafine-induced prolonged cholestasis with reduction of interlobular bile ducts. Dig Dis Sci 1997; 42: 1486-8. (75 year old woman developed weakness followed by jaundice and pruritus several days after completing a 3 week course of terbinafine [bilirubin 5.2 rising to 7.3 mg/dL, ALT 277 U/L, Alk P 375 U/L]; pruritus persisted and biopsy at 6 months showed decrease in bile ducts; symptoms resolved but GGT was still abnormal 17 months later). 9246051
Yao F, Behling CA, Saab S, Li S, Hart M, Lyche KD. Trimethoprim-sulfamethoxazole-induced vanishing bile duct syndrome. Am J Gastroenterol 1997; 92: 167-9. (57 year old man developed VBDS after acute hepatic injury [bilirubin 2.0 rising to 40.4 mg/dL, ALT 465 U/L, Alk P 295 U/L] arising within 1 week of starting TMP-SMZ; no allergic features; ultimately underwent liver transplantation). 8995964
Srivastava M, Perez-Atayde A, Jonas MM. Drug-associated acute-onset vanishing bile duct and Stevens-Johnson syndromes in a child. Gastroenterology 1998; 115: 743-6. (9 year old girl developed fever, rash and jaundice within 10 days of starting ibuprofen [bilirubin 3.3 rising to 15 mg/dL, ALT 649 U/L, Alk P 519 U/L] with Stevens Johnson syndrome and persistent jaundice, liver biopsies showing paucity of bile ducts and progression to cirrhosis within 6 months of onset, despite ursodiol, corticosteroid and tacrolimus therapy). 9721172
Desmet VJ. Histopathology of chronic cholestasis and adult ductopenic syndrome. Clin Liver Dis 1998; 2: 249-64. (Expert review of the histological features and various causes of chronic VBDS). 15560031
Richardet JP, Mallat A, Zafrani ES, Blazquez M, Bognel JC, Campillo B. Prolonged cholestasis with ductopenia after administration of amoxicillin/clavulanic acid. Dig Dis Sci 1999; 44: 1997-2000. (78 year old woman developed jaundice 6 weeks after a 10 day course of amoxicillin/clavulanate [bilirubin 6.3 mg/dL, ALT 775 U/L, Alk P 245], with progressive cholestasis and bile duct paucity on liver biopsy, keratoconjunctivitis sicca and death within 6 months of onset: Case 4). 10548348
Anania FA, Rabin L. Terbinafine hepatotoxicity resulting in chronic biliary ductopenia and portal fibrosis. Am J Med 2002; 112: 741-2. (56 year old woman with jaundice after a short course of terbinafine who developed persistent pruritus and Alk P elevations [550 U/L], liver biopsy 20 months later showing paucity of bile ducts). 12079721
Schwarze C, Schmitz V, Fischer HP, Sauerbruch T, Spengler U. Vanishing bile duct syndrome associated with elevated pancreatic enzymes after short-term administration of amoxicillin. Eur J Gastroenterol Hepatol 2002; 14: 1275-7. (45 year old woman developed jaundice 8 weeks after a 7 day course of amoxicillin and subsequent persistence of cholestasis and pruritus [bilirubin 9.1 mg/dL, ALT 137 U/L, Alk P 949 U/L], a biopsy showed paucity of bile ducts and she died of hepatic failure one year later). 12439126
Basset C, Vadrot J, Denis J, Poupon J, Zafrani ES. Prolonged cholestasis and ductopenia following gold salt therapy. Liver Int 2003; 23: 89-93. (49 year old woman with suspected rheumatoid arthritis developed rash and jaundice one month after starting aurothiopropanol sulphonate injections [bilirubin 7 mg/dL, ALT 5 times, and Alk P 11 times ULN], biopsy showing bile duct injury, slow resolution, ductopenia in follow up liver biopsy). 12654130
Taghian M, Tran TA, Bresson-Hadni S, Menget A, Felix S, Jacquemin E. Acute vanishing bile duct syndrome after ibuprofen therapy in a child. J Pediatr 2004; 145: 273-6. (10 year old girl developed Stevens Johnson syndrome a few days after a second short course of ibuprofen for fever [bilirubin 5.4 mg/dL, ALT 639 U/L, Alk P 1697 U/L], with persistence of jaundice and pruritus and biopsy showing paucity of bile ducts [<50%], resolving slowly on ursodiol with liver test abnormalities lasting more than a year). 15289784
Smith LA, Ignacio JR, Winesett MP, Kaiser GC, Lacson AG, Gilbert-Barness E, González-Peralta RP, Wilsey MJ Jr. Vanishing bile duct syndrome: amoxicillin-clavulanic acid associated intra-hepatic cholestasis responsive to ursodeoxycholic acid. J Pediatr Gastroenterol Nutr 2005; 41: 469-73. (10 year old boy developed jaundice after receiving mebendazole, azithromycin and 5 days of amoxicillin/clavulanate [bilirubin 3.7 rising to 26.5 mg/dL, ALT 210 U/L, Alk P 424 U/L-normal], with biopsy after one month showing ductopenia and slow resolution, laboratory tests falling to normal 2 years later). 16205517
Capra F, Nicolini N, Morana G, Guglielmi A, Capelli P, Vantini I. Vanishing bile duct syndrome and inflammatory pseudotumor associated with a case of anabolic steroid abuse. Dig Dis Sci 2005; 50: 1535-7. (32 year old man developed jaundice 3 months after starting anabolic steroids for muscle building [bilirubin 37.4 mg/dL, ALT 182 U/L, Alk P 212 U/L], with liver biopsy showing paucity of bile ducts, resolving over next 4 months). 16110850
Choi SH, Yang SH, Song YB, Kim HJ, Seo YT, Choi DS, Moon KH, Byun JH, Yu ES. [A case of vanishing bile duct syndrome associated with hypersensitivity to allopurinol]. Korean J Hepatol 2005; 11: 80-5.15788888
Vuppalanchi R, Chalasani N, Saxena R. Restoration of bile ducts in drug-induced vanishing bile duct syndrome due to zonisamide. Am J Surg Pathol 2006; 30: 1619-23. (35 year old man developed jaundice 3 weeks after starting zonisamide for obesity [bilirubin 7.1 mg/dL, ALT 531 U/L, Alk P 578 U/L], with persistence of pruritus and serial biopsies showing return of bile ducts; initially no ducts found in 16 portal areas, at two years ducts present in 22 of 24 portal areas despite persistent Alk P elevations [~650 U/L]). 17122520
Jakab SS, West AB, Meighan DM, Brown RS Jr, Hale WB. Mycophenolate mofetil for drug-induced vanishing bile duct syndrome. World J Gastroenterol 2007; 13: 6087-9. (69 year old man developed rash 3 weeks after starting amoxicillin/clavulanate with subsequent jaundice [bilirubin 1.0 rising to 7.4 mg/dL, ALT 82 GGT 360 U/L], with prolonged jaundice and vanishing bile duct syndrome but subsequent resolution with mycophenolate mofetil therapy). 18023105
Ichikawa T, Sato H, Kaira K, Oh-I S, Kakizaki S, Sato K, Takagi H, Mori M. Prolonged intrahepatic cholestasis after exposure to loxoprofen. Clin Ther 2008; 30: 2402-6. (36 year old woman developed jaundice 5 days after starting loxoprofen [bilirubin 27.5 mg/dL, ALT 470 U/L, Alk P 1082 U/L], liver biopsy showing paucity of bile ducts, with protracted course and slow resolution 14 months after onset). 19167598
Okan G, Yaylaci S, Peker O, Kaymakoglu S, Saruc M. Vanishing bile duct and Stevens-Johnson syndrome associated with ciprofloxacin treated with tacrolimus. World J Gastroenterol 2008; 14: 4697-700. (26 year old woman developed fever and rash 2 weeks after starting ciprofloxacin [bilirubin 4.1 rising to ~32 mg/dL, ALT 326 U/L, Alk P 229 U/L], with persistence of jaundice despite ursodiol and corticosteroids and bile duct paucity on liver biopsy, eventually resolving during tacrolimus therapy). 18698687
Etogo-Asse F, Boemer F, Sempoux C, Geubel A. Acute hepatitis with prolonged cholestasis and disappearance of interlobular bile ducts following tibolone and Hypericum perforatum (St. John's wort). Case of drug interaction? Acta Gastroenterol Belg 2008; 71: 36-8. (57 year old woman developed jaundice two years after starting tibolone and 3 months after starting "infusions" of St. John's wort [bilirubin 6.3 mg/dL, ALT 424 U/L, Alk P 162 U/L], with persistent pruritus and jaundice and liver biopsy showing paucity of bile ducts, recovering over next year on ursodiol; St. John's wort may have altered metabolism of tibolone, a known hepatotoxin). 18396749
Reau NS, Jensen DM. Vanishing bile duct syndrome. Clin Liver Dis 2008; 12: 203-17. (Review of the histology and causes of VBDS, listing 42 agents reported to cause chronic cholestasis and ductopenia). 18242505
Schumaker AL, Okulicz JF. Meropenem-induced vanishing bile duct syndrome. Pharmacotherapy 2010; 30: 953. (60 year old woman developed jaundice and pruritus while on meropenem and 3 weeks after course of ceftriaxone, metronidazole and vancomycin [bilirubin 11.2 rising to 26 mg/dL, ALT 83 U/L, Alk P 1467 U/L], with persistent jaundice and liver biopsy showing absence of bile ducts, improving but not completely resolving over next 6 months on ursodiol). 20812433
Kochar R, Nevah MI, Lukens FJ, Fallon MB, Machicao VI. Vanishing bile duct syndrome in human immunodeficiency virus: nevirapine hepatotoxicity revisited. World J Gastroenterol 2010; 16: 3335-8. (28 year old pregnant woman with HIV infection developed jaundice 4 weeks after starting zidovudine, lamivudine and nevirapine to prevent perinatal transmission of HIV [bilirubin 10.5 mg/dL, ALT 179 U/L, Alk P 496 U/L], with persistent jaundice and liver biopsy showing ductopenia; follow up not provided). 20614492
Gökçe S, Durmaz O, Celtik C, Aydogan A, Güllüoglu M, Sökücü S. Valproic acid-associated vanishing bile duct syndrome. J Child Neurol 2010; 25: 909-11. (8 year old girl developed persistent jaundice and itching 2 months after starting valproic acid [bilirubin rising to 20.2 mg/dL, ALT 118 U/L, Alk P 2787 U/L, normal INR], liver biopsy showing severe bile duct loss, bilirubin falling to normal after 8 months on ursodiol therapy but with persistence of Alk P elevations). 20388938
Juricic D, Hrstic I, Radic D, Skegro M, Coric M, Vucelic B, Francetic I. Vanishing bile duct syndrome associated with azithromycin in a 62-year-old man. Basic Clin Pharmacol Toxicol 2010; 106: 62-5. (62 year old man developed Stevens Johnson syndrome 3 days after a 3 day course of azithromycin and became jaundiced during recovery [bilirubin 15.2 mg/dL, ALT 1545 U/L, Alk P 545 U/L], with persistent jaundice and pruritus and liver biopsy showing absence of interlobular bile ducts at time of transplantation 10 months later). 19906050
Robinson W, Habr F, Manlolo J, Bhattacharya B. Moxifloxacin associated vanishing bile duct syndrome. J Clin Gastroenterol 2010; 44: 72-3. (82 year old man received azithromycin, ceftriaxone and 7 days of moxifloxacin and developed jaundice [bilirubin 15.3 rising to 25.8 mg/dL, ALT 441 U/L, Alk P 821 U/L], with biopsy showing ductopenia with persistence of jaundice; outcome not provided). 19581811
Bhayana H, Appasani S, Thapa BR, Das A, Singh K. Lamotrigine-induced vanishing bile duct syndrome in a child. J Pediatr Gastroenterol Nutr 2012;55:e147-8. (12 year old boy developed rash 2 weeks after starting lamotrigine followed by jaundice [bilirubin 14.8 mg/dL, ALT 321 U/L, Alk P 123 U/L], liver biopsy showing ductal paucity with incomplete recovery on ursodiol and referral for transplantation 2 years later). 22008955
Orman ES, Conjeevaram HS, Vuppalanchi R, Freston JW, Rochon J, Kleiner DE, Hayashi PH; DILIN Research Group. Clinical and histopathologic features of fluoroquinolone-induced liver injury. Clin Gastroenterol Hepatol. 2011; 9: 517-523.e3. (12 cases of liver injury due to fluoroquinolones including one due to moxifloxacin that resulted in VBDS and liver transplantation 16 months after onset of acute cholestatic hepatitis). 21356330
Cho HJ, Jwa HJ, Kim KS, Gang DY, Kim JY. Ursodeoxycholic acid therapy in a child with trimethoprim-sulfamethoxazole-induced vanishing bile duct syndrome. Pediatr Gastroenterol Hepatol Nutr 2013; 16: 273-8. (7 year old boy developed pruritus and jaundice 2 weeks after starting a 4 day course of trimethoprim-sulfamethoxazole for diarrhea [bilirubin 8.4 mg/dL, ALT 220 U/L, Alk P 1028 U/L, GGT 708 U/L], liver biopsy showing paucity of bile ducts and cholestasis, subsequently improving on ursodiol therapy with resolution of jaundice and all liver tests with 4 months of onset). 24511525
Nader K, Mok S, Kalra A, Harb A, Schwarting R, Ferber A. Vanishing bile duct syndrome as a manifestation of Hodgkin's lymphoma: a case report and review of the literature. Tumori 2013; 99: e164-8. (64 year old woman developed jaundice within a few days of starting trimethoprim-sulfamethoxazole for urinary tract infection [bilirubin 15.1 rising to 45 mg/dL, ALT 56 U/L, Alk P 1114 rising to 3412 U/L, INR 1.9], liver biopsy showing paucity of bile ducts and severe cholestasis, a lymph node biopsy showing Hodgkin’s disease, but not responding to chemotherapy and dying of multiorgan failure 1 month after presentation). 24326854
Kawasaki Y, Matsubara K, Hashimoto K, Tanigawa K, Kage M, Iwata A, Nigami H, et al. Nonsteroidal anti-inflammatory drug-induced vanishing bile duct syndrome treated with plasmapheresis. J Pediatr Gastroenterol Nutr 2013; 57: e30-1. (13 year old girl developed fever and received loxoprofen for one day and diclofenac for 2 then developed jaundice [bilirubin 9.8 mg/dL, ALT 478 U/L, Alk P not given], liver biopsy showing paucity of bile ducts, treatment with ursodiol and plasmapheresis with subsequent improvement and resolution liver test abnormalities by two months and follow up liver biopsy sowing “regenerated bile ducts in the portal areas”).
Oppenheimer AP, Koh C, McLaughlin M, Williamson JC, Norton TD, Laudadio J, Heller T, Kleiner DE, High KP, Morse CG. Vanishing bile duct syndrome in human immunodeficiency virus infected adults: a report of two cases. World J Gastroenterol 2013; 19: 115-21. (Two cases; 41 and 39 year old men with HIV infection presented with severe cholestasis while on antiretroviral therapy [bilirubin 4.7 and 10 mg/dL], liver biopsies showing bile duct loss [90% and 100%] and cholestasis, both subsequently dying of multiorgan failure, the cause of the VBDS not being clear in either patient). 23326172
Mason M, Adeyi O, Fung S, Millar BA. Vanishing bile duct syndrome in the context of concurrent temozolomide for glioblastoma. BMJ Case Rep 2014; 2014: bcr2014208117. (62 year old woman with glioblastoma multiforme developed pruritus followed by jaundice 15 days after starting temozolomide [bilirubin 16.9 mg/dL, ALT 747 U/L, Alk P 1402 U/L, INR 0.9], liver biopsy showing absence of bile ducts in 60% of portal areas, but jaundice resolved within 3 and liver test abnormalities within 4 months of stopping).
White JC, Appleman S. Infliximab/Plasmapheresis in vanishing bile duct syndrome secondary to toxic epidermal necrolysis. Pediatrics 2014; 134: e1194-8. (6 year old boy developed fever and cough treated with cefdinir and one week later had abnormal liver tests [bilirubin 2.7 rising to 24 mg/dL, ALT 127 U/L, Alk P 631 U/L, GGT 608 U/L] and toxic epidermal necrolysis with respiratory failure and worsening jaundice; liver biopsy showing absence of bile ducts, therapy with infliximab, corticosteroids and plasmapheresis had little effect and he died of multiorgan failure 50 days after presentation). 25246624
Tekin F, Celik F, Nart D, Akarca U. The first report of oxcarbazepine-induced vanishing bile duct syndrome. J Gastrointestin Liver Dis 2014; 23: 222-3. (55 year old woman with Sjogren syndrome developed jaundice and pruritus 4 weeks after starting oxycarbazepine for seizures [bilirubin 22.7 mg/dL, ALT 110 U/L, Alk P 480 U/L, GGT 1255 U/L], liver biopsy showing no bile ducts, and subsequent progressive course led to septic shock and death1 month after presentation). 24949618
Levine C, Trivedi A, Thung SN, Perumalswami PV. Severe ductopenia and cholestasis from levofloxacin drug-induced liver injury: a case report and review. Semin Liver Dis 2014; 34: 246-51. (67 year old woman developed jaundice 2 months after starting levofloxacin [bilirubin 16.3 mg/dL, ALT 614 U/L, Alk P 483 U/L], liver biopsy showing severe bile duct loss and cholestasis, with slow improvement but persistent jaundice [bilirubin 13.0 mg/dL] when last seen 18 months after onset). 24879988
Kim HY, Yang HK, Kim SH, Park JH. Ibuprofen associated acute vanishing bile duct syndrome and toxic epidermal necrolysis in an infant. Yonsei Med J 2014; 55: 834-7. (7 month old girl developed toxic epidermal necrolysis 2 days after starting ibuprofen for fever [initial bilirubin 0.5 rising to 9.5 mg/dL, ALT 523 U/L, Alk P 500 U/L], liver biopsy showing paucity of bile ducts and cholestasis, improving over the next 3 months: “the biochemical data had shown tendency for resolution”). 24719156
Conrad MA, Cui J, Lin HC. Sertraline-associated cholestasis and ductopenia consistent with vanishing bile duct syndrome. J Pediatr 2016; 169: 313- 5.e1. (15 year old boy with depression developed jaundice 6 months after starting sertraline [bilirubin 8.0 rising to 29.2 mg/dL, ALT 238 U/L, GGT 36 U/L, INR 1.0], biopsy showing decrease in bile ducts and marked cholestasis, but abnormalities resolved within 4 months of stopping sertraline). 26597434
Bakhit M, McCarty TR, Park S, Njei B, Cho M, Karagozian R, Liapakis A. Vanishing bile duct syndrome in Hodgkin's lymphoma: A case report and literature review. World J Gastroenterol 2017; 23: 366-72.28127210
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, et al.; U.S. Drug Induced Liver Injury Network Investigators. Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology 2017; 65: 1267-77.27981596
Xie W, Wang Q, Gao Y, Pan CQ. Vanishing bile duct syndrome with hyperlipidemia after ibuprofen therapy in an adult patient: a case report. BMC Gastroenterol 2018; 18: 142.30268094
Visentin M, Lenggenhager D, Gai Z, Kullak-Ublick GA. Drug-induced bile duct injury. Biochim Biophys Acta Mol Basis Dis 2018; 1864(4 Pt B): 1498-506.28882625
Abugroun A, Colina Garcia I, Ahmed F, Potts S, Flicker M. The first report of atovaquone/proguanil-induced vanishing bile duct syndrome: Case report and mini-review. Travel Med Infect Dis 2019; 32: 101439.31238106
Shah P, Larson B, Wishingrad M, Nissen N, Björnsson E, Sundaram V. Now you see it, now you do not: a case of infliximab-Induced vanishing bile duct syndrome. ACG Case Rep J 2019; 6: e00134.31620531
Tejedor-Tejada J, García-Pajares F, Madrigal Rubiales B. Hepatobiliary and pancreatic: sertraline-induced vanishing bile duct syndrome treated with plasmapheresis. J Gastroenterol Hepatol 2019; 34: 488.30536927
Larrey E, Patouraux S, Spreux A, Canivet CM, Piche T, Tran A, Anty R. Fatal cholestatic hepatitis after a single dose of celecoxib. Clin Res Hepatol Gastroenterol 2019; 43: e82-e85.30449626